# Bosentan

## OVERVIEW

### Introduction

Bosentan is an endothelin receptor antagonist used in the therapy of pulmonary arterial hypertension (PAH). Bosentan has been associated with serum enzyme elevations during therapy and with rare instances of clinically apparent acute liver injury.

### Background

Bosentan (boe sen' tan) is an inhibitor of both the type A and B (ETA and ETB) endothelin receptors. Inhibition of the ET receptors disrupts the intracellular pathways that lead to vasoconstriction thereby causing vasodilation. Because these receptors are found in highest concentration in the lungs, the endothelin receptor antagonists primarily cause vasodilation in the pulmonary vasculature and decrease pulmonary vascular pressure with little effect on systemic blood presssure. In prospective, randomized controlled trials, bosentan was effective in alleviating symptoms, improving exercise tolerance and prolonging the time to clinical worsening in patients with idiopathic pulmonary artery hypertension (PAH). Bosentan was the first endothelin receptor antagonist to be approved in the United States (2001) and it remains in active use. The current indications are for symptomatic PAH, classified as WHO group 1 (primary or idiopathic). Use of bosentan in other forms of PAH (due to heart failure, thromboembolic disease, or pulmonary disease) should be considered experimental as its efficacy in these forms of PAH has not been adequately shown. Because of the potential for hepatotoxicity and teratogenicity, bosentan is available only as a part of a monitoring program in which regular monthly determination of serum enzymes levels and adequate methods for birth control are required. Bosentan is available in tablets of 62.5 and 125 mg under the brand name Tracleer and the recommended dose is 62.5 to 125 mg twice daily. Common side effects include headaches, dizziness, flushing, hypotension, rhinitis and edema.

### Hepatotoxicity

Bosentan is associated with elevations in serum aminotransferase levels above three times the upper limit of the normal range (ULN) in 3% to 18% of patients, averaging 7.6% using currently recommended doses. The enzyme elevations are usually self-limited and are rarely accompanied by symptoms, but can be more marked and persist and require dose reduction or discontinuation (in 3% to 4% of patients). Monthly monitoring of serum aminotransferase levels is recommended, with discontinuation for levels above 8 times the ULN or for values above 5 times the ULN that persist. There have also been rare reports of clinically apparent liver injury with jaundice associated with bosentan use. The onset of illness was usually within 1 to 6 months of starting bosentan, but cases arising during chronic therapy have also been described (Case 1). The enzyme pattern has typically been hepatocellular or mixed. Immunoallergic features are usually not present and autoantibodies are usually absent or present in low titer. Some cases have been severe and fatalities have been reported, but there have been no published reports of chronic hepatitis or vanishing bile duct syndrome attributed to bosentan. Autoimmune and immunoallergic features are usually not present.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver injury due to bosentan is not known. Bosentan is metabolized by the cytochrome P450 system (CYP 2C9 and 3A4) and can induce CYP activity that results in drug-drug interactions, particularly with cyclosporine A and birth control pills.

### Outcome and Management

Serum ALT or AST elevations are not uncommon during bosentan therapy. Elevations above 8 times the ULN should trigger drug discontinuation and avoidance of restarting bosentan. Elevations of 5 to 8 times the ULN should be confirmed with repeat testing and bosentan stopped if aminotransferase values persist at that level or rise with possible restarting if values fall back into the normal range. Elevations between 3 to 5 times the ULN should be confirmed on repeat testing and dose modification or interruption considered. The ALT elevations are usually transient and asymptomatic and may resolve despite continuing the medication without dose adjustment.

Most cases of acute liver injury due to bosentan have been self-limited and have not resulted in acute liver failure or chronic injury. However, isolated cases of acute liver failure have been reported to the sponsor and have led to a strict monitoring program for its use. Patients with acute liver injury who are retreated with bosentan usually redevelop liver injury, for which reason rechallenge should be avoided. Switching patients to other endothelin receptor antagonists has been reported to be safe, without return of the liver test abnormalities, but these studies were done largely in patients with mild-to-moderate serum aminotransferase elevations without symptoms. In cases of clinically apparent liver injury due to bosentan, use of other agents for PAH may be more appropriate and switching to another endothelin receptor antagonist (such as ambrisentan) done with caution. Interestingly, several cases of acute liver injury attributed to the endothelin receptor antagonists have had an apparent rapid beneficial response to corticosteroid therapy, some but not all of which had autoimmune features. If corticosteroids are used, the dose and duration of therapy should be kept to a minimum.

Drug Class: Pulmonary Arterial Hypertension Agents

Other Drugs in the Subclass Endothelin Receptor Antagonists: Ambrisentan, Macitentan

## CASE REPORT

### Case 1. Acute hepatitis during extended therapy with bosentan.

[Modified from: Eriksson C, Gustavsson A, Kronvall T, Tysk C. Hepatotoxicity by bosentan in a patient with portopulmonary hypertension: a case-report and review of the literature. J Gastrointestin Liver Dis 2011; 20: 77-80. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/21451802)]

A 29 year old woman with portopulmonary hypertension due to portal vein thrombosis secondary to splenectomy was treated with bosentan in increasing doses up to 125 mg twice daily. During regular monitoring, her serum enzymes remained normal until 18 months after starting the endothelin receptor antagonist when she developed fatigue, nausea and anorexia followed by jaundice. On admission to the hospital, she was jaundiced, but had no fever, rash or adenopathy. Liver tests results showed a serum bilirubin of 10 mg/dL, ALT 600 U/L, AST 840 U/L, alkaline phosphatase 480 U/L, and INR 1.52 (Table). Tests for hepatitis A, B and C were negative as were autoantibodies. Abdominal ultrasound and CT scans showed no evidence of biliary obstruction. During the following week, serum bilirubin levels rose to 17.4 mg/dL and INR to 1.8, but she had no evidence of hepatic encephalopathy or ascites. Prednisolone was started in a dose of 40 mg daily. She improved rapidly and was able to be discharged one week later. Liver tests fell into the normal range within 6 weeks of the onset of illness. The dose of prednisolone was reduced and was withdrawn after 8 weeks. She was treated for her pulmonary artery hypertension with sildenafil and ambrisentan and serum enzymes remained normal.

#### Key Points

Medication: | Bosentan (250 mg daily)
Pattern: | Mixed (R=2.5)
Severity: | 4+ (jaundice, hospitalization and prolongation of prothrombin time)
Latency: | 18 months
Recovery: | 6 weeks
Other medications: | Unspecified diuretics

#### Laboratory Values

Time After Starting | Time After Stopping | AST* (U/L) | Alk P* (U/L) | Bilirubin (mg/dL) | Other
Bosentan 125 mg twice daily started
0 | Pre | 42 | | 1.2
1 month | | 36 | | 1.0
6 months | | 24 | | 1.1
12 months | | 30 | | 1.3
16 months | | 42 | | 1.3
18 months | | Admitted for jaundice; bosentan stopped
18 months | 0 | 840 | 480 | 9.6 | INR 1.52
| 3 days | 870 | | 12.0
| 6 days | 900 | | 14.6 | INR 1.8
| 9 days | 660 | | 17.5 | Prednisolone started
| 11 days | 408 | | 11.1
| 12 days | 210 | | 8.2
| 15 days | 60 | | 7.3 | Discharged
| 22 days | 24 | | 3.5
19 months | 4 weeks | 42 | | 2.6
| 6 weeks | 24 | | 1.4 | Prednisolone stopped
20 months | 2 months | 24 | | 0.8
Normal Values | | <55 | <110 | <1.2

* Some values estimated from Figure 1. ALT and Alk P converted from µkat to U/L (multiplying by 60) and bilirubin from µmol/L to mg/dL (dividing by 17.1).

#### Comment

The latency to onset of liver injury was 18 months, which is longer than usual. Most cases of liver injury linked to endothelin receptor antagonists have arisen within 2 to 6 months of starting. The injury had a mixed pattern, but was severe and led to initiation of corticosteroid therapy, which was followed by a prompt improvement. Interestingly, the patient later tolerated ambrisentan, another endothelin receptor antagonist without recurrence of liver injury. The lack of cross sensitivity to liver injury between these two agents may relate to their different chemical structures. Bosentan (like sitaxsentan) has a sulfonamide-like central moiety, whereas ambrisentan has a propionic acid based structure.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bosentan – Tracleer®

DRUG CLASS

Pulmonary Arterial Hypertension Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=bosentan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Bosentan | 157212-55-0 | C27-H29-N5-O6-S.H2-O | Bosentan Chemical Structure

## REFERENCES

References updated: 30 September 2017

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Textbook of hepatotoxicity published in 1999, before the availability of bosentan and the endothelin receptor antagonists).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on drug induced liver injury; clinical features of liver injury due to bosentan and the endothelin receptor antagonists are not specifically discussed).
Fattinger K, Funk C, Pantze M, Weber C, Reichen J, Stieger B, Meier PJ. The endothelin antagonist bosentan inhibits the canalicular bile salt export pump: a potential mechanism for hepatic adverse reactions. Clin Pharmacol Ther 2001; 69: 223-31. (Analysis of safety databases from 3 premarketing controlled trials of bosentan showed a dose related rate of ALT elevations [>3 times ULN] from 0% [0-20 mg/d] to 2-4% [100-500 mg/d] to 8-11% [1000-2000 mg/d] and concurrent rise in bile acid levels with minor increase in Alk P, but no change in bilirubin levels or clinically apparent liver injury; similar rate related rise in bile acids [but not ALT] in rats given bosentan). 11309550
Channick RN, Simonneau G, Sitbon O, Robbins IM, Frost A, Tapson VF, Badesch DB, et al. Effects of the dual endothelin-receptor antagonist bosentan in patients with pulmonary hypertension: a randomised placebo-controlled study. Lancet 2001; 358: 1119-23. (Controlled trial of bosentan [250 mg daily] vs placebo for at least 12 weeks in 32 patients with PAH; 2 of 21 patients receiving bosentan developed ALT elevations which resolved without need for discontinuation). 11597664
Barst RJ, Rich S, Widlitz A, Horn EM, McLaughlin V, McFarlin J. Clinical efficacy of sitaxsentan, an endothelin-A receptor antagonist, in patients with pulmonary arterial hypertension: open-label pilot study. Chest 2002; 121: 1860-8. (Open label study of 12 weeks of sitaxsentan in doses of 100 to 500 mg daily in 20 patients with PAH; during extension phase, ALT elevations occurred in 35% of patients and 2 developed jaundice; both cases were 53 year old women with PAH who developed enzyme elevations between 12 and 18 weeks of therapy [peak bilirubin 8.6 and 45.7 mg/dL; ALT 514 and 1041 U/L, Alk P 620 and 233 U/L], the first recovered within 3 months and the second died of acute liver failure). 12065350
Rubin LJ, Badesch DB, Barst RJ, Galie N, Black CM, Keogh A, Pulido T, et al. Bosentan therapy for pulmonary arterial hypertension. N Engl J Med 2002; 346: 896-903. (Controlled trial of 2 doses of bosentan vs placebo in 213 patients with PAH; abnormal liver tests arose in 4% on 125 mg, 10% on 250 mg and 3% on placebo, but no patient developed clinically apparent liver injury). 11907289
Barst RJ, Langleben D, Frost A, Horn EM, Oudiz R, Shapiro S, McLaughlin V, et al; STRIDE-1 Study Group. Sitaxsentan therapy for pulmonary arterial hypertension. Am J Respir Crit Care Med 2004; 169: 441-7. (Controlled trial of 2 doses of sitaxsentan vs placebo for 12 weeks in 178 patients with PAH found ALT elevations [above 3 times ULN] in 3% of placebo, 0% of sitaxsentan [100 mg daily] and 10% [300 mg daily], the latter rates increasing with extended therapy to 5% and 21%; no mention of clinically apparent liver injury or jaundice). 14630619
McLaughlin VV, Sitbon O, Badesch DB, Barst RJ, Black C, Galiè N, Rainisio M, et al. Survival with first-line bosentan in patients with primary pulmonary hypertension. Eur Respir J 2005; 25: 244-9. (Extended follow up of 169 patients with PAH treated with bosentan for an average of 2 years; ALT elevations above 3 times ULN occurred in 15%, between 5 and 8 times ULN in 3% and above 8 times ULN in 4.2%). 15684287
Segal ES, Valette C, Oster L, Bouley L, Edfjall C, Herrmann P, Raineri M, et al. Risk management strategies in the postmarketing period : safety experience with the US and European bosentan surveillance programmes. Drug Saf 2005; 28: 971-80. (Description of a US and a European postmarketing system for monitoring safety of bosentan, which allows for estimation of rate of hepatic adverse events, the estimate for serum enzyme elevations being 7.7%). 16231952
Barst RJ, Langleben D, Badesch D, Frost A, Lawrence EC, Shapiro S, Naeije R, Galie N; STRIDE-2 Study Group. Treatment of pulmonary arterial hypertension with the selective endothelin-A receptor antagonist sitaxsentan. J Am Coll Cardiol 2006; 47: 2049-56. (Controlled trial of 18 weeks of sitaxsentan [50 or 100 mg daily] vs open label bosentan [125 mg twice daily] vs placebo in 245 patients with PAH; ALT or AST elevations occurred in 6% on placebo, 3-5% on sitaxsentan and 11% on bosentan, reversing in all with time, stopping or dose adjustment). 16697324
Suntharalingam J, Hodgkins D, Cafferty FH, Hughes RJ, Pepke-Zaba J. Does rapid dose titration affect the hepatic safety profile of Bosentan? Vascul Pharmacol 2006; 44: 508-12. (Comparison of patients with rapid [n=55] or slow [n=94] bosentan dose increase [125 to 250 mg/d] during initiation of therapy found no difference in rate of ALT elevations above 3 times ULN [6% vs 15%]; 8 patients required discontinuation). 16713365
McIntyre K. Drug-related hepatotoxicity. N Engl J Med 2006; 354: 2191-3. (Letter in response to a review article on hepatotoxicity mentions the problem of the endothelin receptor antagonists). 16710914
Galiè N, Beghetti M, Gatzoulis MA, Granton J, Berger RM, Lauer A, Chiossi E, et al; Bosentan Randomized Trial of Endothelin Antagonist Therapy-5 (BREATHE-5) Investigators. Bosentan therapy in patients with Eisenmenger syndrome: a multicenter, double-blind, randomized, placebo-controlled study. Circulation 2006; 114: 48-54. (Controlled trial of bosentan vs placebo for 16 weeks in 54 patients with PAH and Eisenmenger syndrome found only one patient required discontinuation of drug for ALT elevations; among 37 treated long term, ALT elevations above 3 times ULN occurred in 5.4%). 16801459
Diller GP, Dimopoulos K, Kaya MG, Harries C, Uebing A, Li W, Koltsida E, et al. Long-term safety, tolerability and efficacy of bosentan in adults with pulmonary arterial hypertension associated with congenital heart disease. Heart 2007; 93: 974-6. (Among 18 patients with PAH treated with bosentan [125 mg twice daily] for average of 2 years, none had ALT rise above 3 times ULN). 17639112
Benza RL, Mehta S, Keogh A, Lawrence EC, Oudiz RJ, Barst RJ. Sitaxsentan treatment for patients with pulmonary arterial hypertension discontinuing bosentan. J Heart Lung Transplant 2007; 26: 63-9. (Controlled trial of two doses of sitaxsentan in 48 patients with PAH who had discontinued bosentan because of safety problems or lack of efficacy, found that side effects were few, and only 1 of 12 patients who had ALT elevations [above 3 times ULN] during bosentan therapy had similar elevations on sitaxsentan). 17234519
Humbert M, Segal ES, Kiely DG, Carlsen J, Schwierin B, Hoeper MM. Results of European post-marketing surveillance of bosentan in pulmonary hypertension. Eur Respir J 2007; 30: 338-44. (Description and analysis of the internet based system of monitoring safety in patients receiving bosentan in Europe; in the first 30 months, 4994 patients were enrolled and annual rate of ALT or AST elevation above 3 times ULN was 10.1% [1.3% were >8 times ULN]; 3.2% of patients discontinued therapy because of enzyme elevations, and 11 of 45 patients redeveloped enzyme elevations with reintroduction of bosentan; no mention of clinically apparent liver injury). 17504794
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to an endothelin receptor antagonist). 18955056
Dupuis J, Hoeper MM. Endothelin receptor antagonists in pulmonary arterial hypertension. Eur Respir J 2008; 31: 407-15. (Review of the mechanism of action and clinical efficacy of endothelin receptor antagonists). 18238950
Nagai Y, Okada E, Mihara S, Sato K, Ohi S, Ishikawa O. Severe liver dysfunction due to bosentan in a patient with mixed connective tissue disease. Eur J Dermatol 2008; 18: 190-1. (70 year old woman with connective tissue disease and digital ulcers developed ALT elevations [77 U/L] 2 months after starting bosentan, which rapidly worsened [ALT 3597 U/L, bilirubin and Alk P not given] despite stopping bosentan, and progressed to multiorgan failure and death within 2 weeks). 18424383
Galié N, Rubin Lj, Hoeper M, Jansa P, Al-Hiti H, Meyer G, Chiossi E, et al. Treatment of patients with mildly symptomatic pulmonary arterial hypertension with bosentan (EARLY study): a double-blind, randomised controlled trial. Lancet 2008; 371: 2093-100. (Controlled trial of bosentan [n=93] vs placebo [n=92] for 6 months; serum ALT rose above 3 times ULN in 13% of bosentan vs 2% of placebo treated patients, mostly in first 20 weeks and resolving spontaneously in many without dose adjustment and without clinically apparent liver injury). 18572079
Sethi S, Sethi R, Wareham C. Hidden hazards of Bosentan therapy in pulmonary hypertension. Ann Card Anaesth 2008; 11: 138. (Letter in response to a review of therapy of PAH emphasizing serious potential side effects of bosentan including hepatotoxicity). 18603762
Hoeper MM, Olsson KM, Schneider A, Golpon H. Severe hepatitis associated with sitaxentan and response to glucocorticoid therapy. Eur Respir J 2009; 33: 1518-9. (25 year old woman developed ALT elevations 4 months after starting sitaxsentan [bilirubin 1.8 mg/dL, ALT 1000 U/L, Alk P not given], which responded rapidly to prednisolone therapy). 19483056
Lavelle A, Sugrue R, Lawler G, Mulligan N, Kelleher B, Murphy DM, Gaine SP. Sitaxentan-induced hepatic failure in two patients with pulmonary arterial hypertension. Eur Respir J 2009; 34: 770-1. (2 cases; 47 year old man developed jaundice 4 months after starting sitaxsentan [bilirubin 21.2 mg/dL, ALT 1550 U/L, INR 1.6], ultimately resolving; 70 year old woman developed jaundice 5 months after starting sitaxsentan [bilirubin 4.0 rising to 25.1 mg/dL, ALT 1198 U/L, INR 1.6], dying of respiratory failure a few months later). 19720812
Hoeper MM. Liver toxicity: the Achilles' heel of endothelin receptor antagonist therapy? Eur Respir J 2009; 34: 529-30. (Editorial in response to Lavelle [2009] recounting the history of development of endothelin receptor antagonists and the problem of hepatotoxicity, stressing the need for "pharmacovigilance"). 19720805
McGoon MD, Frost AE, Oudiz RJ, Badesch DB, Galie N, Olschewski H, McLaughlin VV, Gerber MJ, Dufton C, Despain DJ, Rubin LJ. Ambrisentan therapy in patients with pulmonary arterial hypertension who discontinued bosentan or sitaxsentan due to liver function test abnormalities. Chest 2009; 135: 122-9. (36 patients with PAH who had ALT elevations during bosentan [n=31] or sitaxsentan [n=2] therapy were treated with ambrisentan for average of 2 years and only one had transient ALT elevation [3.2 times ULN] that resolved on stopping, and did not recur upon restarting and long term treatment). 18812445
Mulchey K, Bshouty Z. An atypical presentation of liver enzyme elevation resulting from bosentan use. Can Respir J 2009; 16: e54-6. (71 year old woman with PAH developed jaundice 5 months after starting bosentan [bilirubin 20.1 mg/dL, ALT 446 U/L], which resolved upon stopping but ALT levels rose immediately [bilirubin 1.3 mg/dL, ALT 163 U/L] on restarting at a lower dose). 19851530
Dwyer N, Jones G, Kilpatrick D. Severe hepatotoxicity in a patient on bosentan upon addition of methotrexate: reversible with resumption of methotrexate without bosentan. J Clin Rheumatol 2009; 15: 88-9. (45 year old woman with scleroderma developed jaundice 15 months after starting bosentan and 4 months after starting methotrexate [bilirubin 9.6 mg/dL, ALT 1189 U/L, Alk P 550 U/L], resolving within 4 weeks of stopping and not recurring when methotrexate was restarted at a lower dose). 19265355
Mathier MA, Ishizawar D. Bosentan. Expert Opin Pharmacother 2010; 11: 1023-34. (Review of the mechanism of action, pharmacokinetics, metabolism, safety and efficacy of bosentan; on conventional doses of bosentan, ALT elevations arise in 7.6% of patients and lead to discontinuation in 3.2%). 20307226
Eriksson C, Gustavsson A, Kronvall T, Tysk C. Hepatotoxicity by bosentan in a patient with portopulmonary hypertension: a case-report and review of the literature. J Gastrointestin Liver Dis 2011; 20: 77-80. (29 year old woman developed jaundice 18 months after starting bosentan [bilirubin ~10 mg/dL, ALT 600 U/L, Alk P 480 U/L, INR 1.3], worsening for several weeks and then rapid improvement on starting prednisolone which ultimately could be withdrawn without relapse). 21451802
Lee WT, Kirkham N, Johnson MK, Lordan JL, Fisher AJ, Peacock AJ. Sitaxentan-related acute liver failure in a patient with pulmonary arterial hypertension. Eur Respir J 2011; 37: 472-4. (19 year old woman developed jaundice 3 months after starting sitaxsentan [bilirubin 10.1 mg/dL, ALT 1250 U/L, Alk P 188 U/L, protime 16 sec], progressing to hepatic failure and death 13 days after presentation). 21282815
Galié N, Hoeper MM, Simon J, Gibbs R, Simonneau G; Task Force for the Diagnosis and Treatment of Pulmonary Hypertension of the European Society of Cardiology(ESC) and the European Respiratory Society (ERS). Liver toxicity of sitaxentan in pulmonary arterial hypertension. Eur Heart J 2011; 32: 386-7. (Review of reports of hepatotoxicity of endothelin receptor antagonists identified 9 cases of severe liver injury from sitaxsentan, including 4 deaths and one liver transplant, compared to no instances of acute liver failure due to ambrisentan [10,000 patients exposed] or bosentan [80,000 patients exposed]). 21416695
Rubin LJ. Endothelin receptor antagonists for the treatment of pulmonary artery hypertension. Life Sci 2012; 91: 517-21. (Review of the mechanism of action and clinical efficacy of endothelin receptor antagonists in PAH, with mention of need to monitor serum aminotransferase levels during bosentan therapy). 22884806
Don GW, Joseph F, Celermajer DS, Corte TJ. Ironic case of hepatic dysfunction following the global withdrawal of sitaxentan. Intern Med J 2012; 42: 1351-4. (53 year old woman with scleroderma and PAH developed liver injury 3 weeks after starting bosentan and having tolerated sitaxentan [peak bilirubin ~3.5, ALT 300 U/L, Alk P 110 U/L], worsening for a week and resolving over the month). 23253000
Savale L, Magnier R, Le Pavec J, Jaïs X, Montani D, O'Callaghan DS, Humbert M, et al. Efficacy, safety, and pharmacokinetics of bosentan in portopulmonary hypertension. Eur Respir J 2013; 41: 96-103. (Retrospective analysis of 34 patients with cirrhosis and portopulmonary hypertension treated with bosentan, serum ALT elevations above 3 times the ULN occurred in 7 for an annual rate of 5.5%, frequently leading to drug discontinuation, but not associated with jaundice or hepatic decompensation). 22653773
Markova SM, De Marco T, Bendjilali N, Kobashigawa EA, Mefford J, Sodhi J, Le H, et al. Association of CYP2C9*2 with bosentan-induced liver injury. Clin Pharmacol Ther 2013; 94: 678-86. (Among 56 Caucasian patients with PAH treated with bosentan, elevations in serum ALT levels and liver injury were found to be associated with CYP2C9*2 polymorphism, which was also associated with reduced bosentan metabolism in vitro). 23863877
Watkins PB. Managing the risk of drug-induced liver injury. Clin Pharmacol Ther 2013; 94: 629-31. (Editorial in response to Markova [2013] discussing the risks of liver injury from bosentan, the risk management reduction program used for patients needing the drug, and the newly reported link of this injury with CYP2C9*2). 24241638
Macías Saint-Gerons D, de la Fuente Honrubia C, Montero Corominas D, Catalá-López F. [Hepatotoxicity in patients treated with endothelin receptor antagonists: Systematic review and meta-analysis of randomized clinical trials.]. Med Clin (Barc) 2014; 142: 333-42. Spanish. (Systematic review of the literature, including 21 trials in 3644 patients, found relative risk of ALT or AST elevations above 3 times ULN to be 2.98 for endothelin receptor antagonists compared to placebo controls). 23540381
Ito T, Ozaki Y, Son Y, Nishizawa T, Amuro H, Tanaka A, Tamaki T, et al. Combined use of ursodeoxycholic acid and bosentan prevents liver toxicity caused by endothelin receptor antagonist bosentan monotherapy: two case reports. J Med Case Rep 2014; 8: 250. (Two women, ages 64 and 69, with systemic sclerosis and PAH developed elevations in ALT [~180 and 75 U/L] and Alk P [~1100 and 900 U/L] on bosentan, which resolved on stopping and did not recur when bosentan combined with ursodiol was restarted). 25015229
Roustit M, Fonrose X, Montani D, Girerd B, Stanke-Labesque F, Gonnet N, Humbert M, et al. CYP2C9, SLCO1B1, SLCO1B3, and ABCB11 polymorphisms in patients with bosentan-induced liver toxicity. Clin Pharmacol Ther 2014; 95: 583-5. (Among 9 subjects who developed abnormal liver tests during bosentan therapy requiring discontinuation and 14 controls, no association was found between polymorphisms of several genes involved with bosentan pharmacokinetics and occurrence of liver injury). 24842639
Naito A, Terada J, Tanabe N, Sugiura T, Sakao S, Kanda T, Yokosuka O, Tatsumi K. Autoimmune hepatitis in a patient with pulmonary arterial hypertension treated with endothelin receptor antagonists. Intern Med 2014; 53: 771-5. (48 year old woman with idiopathic PAH and ANA positivity [1:1,280] developed ALT elevations [421 U/L] 5 years after starting bosentan, which resolved on stopping but recurred [ALT 521 U/L] 1 year after starting ambrisentan, resolving on stopping but arising again [ALT ~ 250 U/L], resolving with prednisolone therapy after biopsy showed autoimmune hepatitis). 24694495
Blanchette CM, Nunes AP, Lin ND, Mortimer KM, Noone J, Tangirala K, Johnston S, et al. Adherence to risk evaluation and mitigation strategies (REMS) requirements for monthly testing of liver function. Drugs Context 2015; 4. pii: 212272. (Analysis of claims of bosentan and for laboratory services in a large research database identified 523 patients, but high rates of non-adherence to recommendations for regular ALT and AST monitoring, 29% having less than 50% on-therapy testing). 25709706
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one was attributed to bosentan, but none to macitentan, ambrisentan or other agents used primarily to treat pulmonary artery hypertension). 25754159
Packer M, McMurray JJV, Krum H, Kiowski W, Massie BM, Caspi A, Pratt CM, et al; ENABLE Investigators and Committees. Long-term effect of endothelin receptor antagonism with bosentan on the morbidity and mortality of patients with severe chronic heart failure: primary results of the ENABLE trials. JACC Heart Fail 2017; 5: 317-326. (Among 1613 patients with heart failure enrolled in two clinical trials and treated with bosentan or placebo for a median of 1.5 years, rates of clinical worsening and death were similar in the two groups while ALT elevations above 3 times ULN occurred in 9.7% treated with bosentan vs 3.4% on placebo, mostly during the first 6 months of treatment, but no patient developed acute hepatitis or died of liver failure). 28449795
Wei A, Gu Z, Li J, Liu X, Wu X, Han Y, Pu J. Clinical adverse effects of endothelin receptor antagonists: insights from the meta-analysis of 4894 patients from 24 randomized double-blind placebo-controlled clinical trials. J Am Heart Assoc 2016; 5. pii: e003896. (Systematic review of 24 randomized trials of endothelin receptor antagonists indicated higher rates of "abnormal liver function" in patients receiving bosentan and macitentan, but not ambrisentan). 27912207
Safdar Z, Thakur A, Frost A. Tolerability of switch to macitentan from bosentan in pulmonary arterial hypertension. South Med J 2017; 110: 223-228. (Among 24 patients with PAH switched from bosentan to macitentan for unstated reasons, mean serum ALT and AST did not change although one patient had to stop macitentan because of ALT elevations). 28257550

## OTHER REFERENCE LINKS

1. Recent References on Bosentan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(bosentan/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Bosentan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=bosentan)